# Simvastatin

## OVERVIEW

### Introduction

Simvastatin is a commonly used cholesterol lowering agent (statin) that is associated with mild, asymptomatic and self-limited serum aminotransferase elevations during therapy, and rarely with clinically apparent acute liver injury.

### Background

Simvastatin (sim" va stat' in) is an orally available inhibitor of hepatic 3-hydroxy-3-methylglutaryl-coenzyme A (HMG-CoA) reductase, the major rate-limiting enzyme in cholesterol synthesis. Like other members of its class (the “statins”), simvastatin lowers total serum cholesterol and particularly low density lipoprotein (LDL) cholesterol concentrations, thereby reducing the risk of atherosclerosis and its complications – myocardial infarction and stroke. Simvastatin was approved for use in the United States in 1991 and is still widely used with more than 40 million prescriptions being filled yearly. Current indications for simvastatin are hypercholesterolemia and reduction in risk for death from coronary, cerebrovascular and peripheral artery disease in patients with these diseases. Simvastatin is available generic forms and under the commercial name of Zocor in tablets of 5, 10, 20, 40 and 80 mg. the recommended dose is 5 to 80 mg daily based upon tolerability and lipid levels. Simvastatin is also available as a fixed combination with ezetimibe under the brand name Vytorin. Common side effects include muscle cramps, joint aches, abdominal pain, nausea, headache and weakness, symptoms that occur with all of the currently available statins. Rare but potentially severe adverse events include liver injury, myopathy, rhabdomyolysis, and immune-mediated necrotizing myopathy.

### Hepatotoxicity

Up to 5% of patients taking simvastatin chronically may experience minor elevations in serum ALT levels during therapy, but confirmed elevations to above three times the upper limit of normal (ULN) occur in only 1% to 2% of patients. These abnormalities are usually asymptomatic and self-limited even if therapy is continued. ALT elevations are clearly more frequent in patients taking higher doses of simvastatin (40 and 80 mg daily). In several studies, ALT elevations were no more frequent in patients taking 10 and 20 mg of simvastatin daily than in placebo recipients. Clinically apparent liver injury due to simvastatin is rare. The usual latency to onset of symptoms of liver disease ranges from one week to as long as 3 years, but most cases have a latency of 1 to 6 months. The pattern of injury is variable, hepatocellular, cholestatic or mixed patterns have been described. Immunoallergic symptoms of fever and rash are uncommon. Isolated cases of an autoimmune hepatitis-like syndrome associated with simvastatin therapy have been reported, some of which did not reverse completely with discontinuation, resulting in a chronic hepatitis requiring long term immunosuppressive therapy. In most cases, however, recovery occurs within 1 to 3 months. Rare cases of acute liver failure and death have been attributed to simvastatin. But in view of the wide use of simvastatin, clinically apparent liver injury is exceeding rare and is estimated to occur in 1 per 100,000 patient years of exposure.

Likelihood score: A (well known but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from simvastatin is unknown. Simvastatin is metabolized to some extent in the liver (via CYP 3A4) and is excreted in bile. The mild, self-limited ALT elevations are likely due to a toxic intermediate of drug metabolism and the reversal of these elevations due to adaptation. Use of simvastatin is contraindicated in medications that are strong inhibitors of cytochrome P450 activity (such as cyclosporine, ketoconazole, diltiazem, ciprofloxacin or amiodarone), and dose adjustments are appropriate for its use with other agents that inhibit CYP 3A4. Coadministration with these agents may cause increases in simvastatin levels and potentiate its hepatic or muscle toxicity. Both the liver enzyme elevations and muscle effects of simvastatin appear to be the result of direct toxicity and are associated largely with use of higher doses, administration with drugs that interact with its metabolism and the presence of significant comorbidities. In contrast, the idiosyncratic, clinically apparent liver injury associated with simvastatin is idiosyncratic and is likely to be immunologically mediated and is not particularly dose-related.

### Outcome and Management

The product label for simvastatin recommends screening for liver test abnormalities before starting therapy and repeating tests as clinically indicated. The mild ALT elevations associated with simvastatin therapy are usually self-limited and do not require dose modification. Simvastatin should be stopped if ALT levels rise above 10-fold the upper limit of normal, or persist in being above 5-fold elevated or are associated with symptoms. In the clinically apparent liver injury attributed to simvastatin, recovery is usually complete within 1 to 2 months. Vanishing bile duct syndrome due to simvastatin has not been described. Rare instances of acute liver failure have been attributed to simvastatin, but in these cases the role of simvastatin was not completely clear. In view of the wide scale use of simvastatin, clinically apparent and severe liver injury is extraordinarily rare. Recurrence of injury with rechallenge has been reported and should be avoided. Switching therapy to another statin after simvastatin induced injury is apparently safe, but few instances have been reported, and it should be done with careful monitoring for recurrence.

Drug Class: Antilipemic Agents

Other Drugs in the Subclass, Statins: Atorvastatin, Ezetimibe [used in combination], Fluvastatin, Lovastatin, Pitavastatin, Pravastatin, Rosuvastatin

## CASE REPORTS

### Case 1. Cholestatic hepatitis due to simvastatin.(1)

A 67 year old woman was admitted to the hospital with a 2 week history of jaundice, pruritus, right upper quadrant pain and fatigue that had arisen 10 months after starting simvastatin (10 mg daily for 8 months, 5 mg for 2) for hypercholesterolemia. She had suffered an ischemic stroke the year before and was taking nitroglycerin and aspirin chronically. She had no history of liver disease and drank little alcohol. On examination, she was jaundiced. Laboratory tests showed moderate elevations of aminotransferase and alkaline phosphatase levels (Table). Tests for hepatitis B and C were negative as were autoantibodies. Imaging of the abdomen showed no evidence of biliary obstruction. Simvastatin was stopped and she was treated with ursodiol, cholestyramine and prednisone (50 mg daily). She improved slowly and was discharged from the hospital 3 weeks later with no symptoms and minimal jaundice. In follow up 4 weeks later, her blood tests were normal.

#### Key Points

Medication: | Simvastatin (5-10 mg daily)
Pattern: | Cholestatic (R=0.6→1.3)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 10 months
Recovery: | 7 weeks
Other medications: | Nitroglycerin, aspirin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
10 months | 0 | 85 | 420 | 8.2 | Admission
| 1 week | 165 | 360 | 11.3
11 months | 3 weeks | 85 | 240 | 3.0
12 months | 7 weeks | Normal | Normal | Normal
Normal Values | | <42 | <120 | <1.2

* Some values estimated from Table 1.

#### Comment

The latency to onset of liver injury due to simvastatin is quite variable, ranging from a few weeks to several years. Nevertheless, the acute cholestatic course, resolution with stopping simvastatin and lack of other diagnoses make it likely that the injury in this case was due to simvastatin. The role of prednisone in managing acute cholestatic injury due to medications is unclear. While therapy may appear to improve jaundice and symptoms promptly, it is doubtful whether the ultimate outcome of the hepatic injury is changed by therapy and the risks of using high doses of prednisone are not negligible.

### Case 2. Acute liver failure attributed to simvastatin/ezetimibe therapy.(2)

A 70 year old woman developed abnormal liver tests ten weeks after switching from simvastatin (40 mg) monotherapy to the combination of simvastatin (40 mg) and ezetimibe (10 mg) daily. She had a history of coronary artery disease, hypertension, depression and hypercholesterolemia and had been on simvastatin for one and a half years with normal serum enzymes (Table). Despite stopping both simvastatin and ezetimibe, she developed jaundice and progressive symptoms of liver failure. Tests for hepatitis A, B and C were negative as were autoimmune markers. A liver biopsy showed changes suggestive of drug induced liver injury and severe cholestasis. She developed progressive encephalopathy and worsening coagulation indices, and was listed and underwent successful liver transplantation approximately 4 weeks after stopping therapy. In follow up for two years after transplantation, liver enzymes were normal.

#### Key Points

Medication: | Simvastatin and ezetimibe
Pattern: | Hepatocellular (R=25)
Severity: | 5+ (emergency liver transplantation)
Latency: | 10 weeks to liver test abnormalities, 12 weeks to jaundice
Recovery: | None
Other medications: | Enalapril, escitalopram chronically

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 19 | 65 | 0.5 | Before starting simvastatin
0 | | 14 | 51 | 0.4 | On simvastatin before ezetimibe
10 | 0 | 842 | | 0.4 | Simvastatin and ezetimibe stopped
12 | 2 | 2595 | 217 | 45.8 | Admitted
14 | 4 | 1951 | 116 | 21.6 | INR=2.0
Emergency liver transplantation performed
Post-op day 1 | | 209 | 83 | 8.4
Post-op day 23 | | 39 | 82 | 1.0
2 years after transplant | | 18 | 79 | 0.5
Normal Values | | <56 | <126 | < 1.2

#### Comment

The onset of injury 10 weeks after starting ezetimibe suggests that it was the cause of the acute liver injury, but onset of hepatitis due to simvastatin can occur months to years after its initiation. This is one of the few case reports of acute liver failure due to a cholesterol lowering agent.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Simvastatin – Generic, Zocor®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=simvastatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Simvastatin | 79902-63-9 | C25-H38-O5

## CITED REFERENCES

1 Lata S, Chudy B. (2006). Przegl Lek.
2 Tuteja S, Pyrsopoulos NT, Wolowich WR, Khanmoradi K, Levi DM, Selvaggi G, Weisbaum G, et al. (2008). Simvastatin-ezetimibe-induced hepatic failure necessitating liver transplantation. Pharmacotherapy.

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2021

Abbreviations used: ANA, antinuclear antibody; HDL, high density lipoprotein; LDL, low density lipoprotein; OD, odds ratio.

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999; the statins have dose related hepatic effects in guinea pigs and rabbits, and transient elevations in aminotransferases occur in 1-5% of humans treated; several cases of clinically apparent liver injury from lovastatin and simvastatin have been published).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. Lipid lowering agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of lipid lowering agents; asymptomatic elevations in aminotransferases are common in patients receiving statins, but clinically significant hepatotoxicity is rare).
Gurgle H, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-618. (Textbook of pharmacology and therapeutics; “Serious hepatotoxicity is rare and unpredictable, with a rate of about 1 case per million person-years of use.” Multiple academic societies and the FDA recommend testing all patients for routine liver tests before starting statins but monitoring or retesting only if symptoms arise).
Feydy P, Bogomoletz WV. (1991). Gastroenterol Clin Biol. (61 year old man developed abdominal pain 60 days after starting simvastatin [bilirubin 3.0 rising to 11.9 mg/dL, ALT 11.2 times ULN, Alk P normal], resolving completely with 6 months of stopping).
Molgaard J, Lundh BL, von Schenk H, Olsson AG. (1991). Long-term efficacy and safety of simvastatin alone and in combination therapy in treatment of hypercholesterolemia. Atherosclerosis. (Among 51 patients with treated with simvastatin, ALT or AST elevations occurred in 52%, but all were <3 times ULN and all resolved).
Boccuzzi SJ, Bocanegra TS, Walker JF, Shapiro DS, Keggan ME. (1991). Long-term safety and efficacy profile of simvastatin. Am J Cardiol. (In prelicensure controlled trials, ALT elevations >3 times ULN occurred in 1.4% of simvastatin vs 2.7% placebo treated subjects, with similar rates of discontinuation [0.2% vs 0.3%] and no clinically apparent liver injury).
Ballare M, Campanini M, Catania E, Bordin G, Zaccala G, Monteverde A. (1991). Acute cholestatic hepatitis during simvastatin administration. Recento Prog Med. (60 year old woman developed jaundice after 1 month of simvastatin therapy [bilirubin 14.9 mg/dL, ALT 661 U/L, Alk P 487 U/L], resolving within 6 weeks of stopping drug).
England JD, Viles A, Labib S. (1991). Liver side effects associated with simvastatin therapy. Med J Aust. (58 year old developed malaise within 1 day of starting simvastatin [bilirubin twice normal, ALT 2490 U/L, Alk P 256 U/L], abnormalities resolving within 4 months after stopping).
Ballarè M, Campanini M, Airoldi G, Zaccala G, Bertoncelli MC, Cornaglia G, Porzio M, et al. (1992). Hepatotoxicity of hydroxy-methyl-glutaryl-coenzyme A reductase inhibitors. Minerva Gastroenterol Dietol. (Prospective monitoring identified ALT elevations in 5% of 100 patients on simvastatin and 4.5% of 90 on pravastatin).
Roblin X, Becot F, Piquemal A, Baziz A. (1992). Gastroenterol Clin Biol. (48 year old man developed abnormal ALT [99 U/L] and GGT [289 U/L] with normal bilirubin and Alk P levels and without symptoms 6 months after starting simvastatin, resolving within a month of stopping).
Keech A, Collins R, MacMahon S, Armitage J, Lawson A, Wallendszus K, Fatemian M, et al., Oxford Cholesterol Study Group. (1994). Three-year follow-up of the Oxford Cholesterol Study: assessment of the efficacy and safety of simvastatin in preparation for a large mortality study. Eur Heart J. (Controlled trial of two doses of simvastatin vs placebo in 621 patients with average duration of 3.4 years; ALT elevations were not uncommon, but elevations >3 times ULN occurred in only 2 patients, both on placebo).
Koornstra JJ, Ottervanger JP, Fehmers MC, Stricker BH. (1996). Ned Tijdschr Geneeskd. (Six cases of hepatitis due to simvastatin from the Netherlands reporting system, 3 men and 3 women, ages 47 to 69 years, developed liver injury 3 months to 3 years after starting simvastatin [bilirubin rised in all, ALT 1.8 to 74 times ULN, Alk P 1.5 to 3.9 times ULN], 5 recovered in 1-3 months, one died, one had positive rechallenge).
Pedersen TR, Berg K, Cook TJ, Faergerman O, Haghfelt T, Kjekshus J, Mietinen T, et al. (1996). Safety and tolerability of cholesterol lowering with simvastatin during 5 years in the Scandinavian Simvastatin Survival Study. Arch Intern Med. (Controlled trial of simvastatin vs placebo assessing morbidity and mortality in persons with cardiovascular disease; no significant difference in frequency of ALT levels >3x ULN between recipients of simvastatin vs placebo).
Davidson MH, Stein EA, Dujovne CA, Hunninghake DB, Weiss SR, Knopp RH, Illingworth DR, et al. (1997). The efficacy and six-week tolerability of simvastatin 80 and 160 mg/day. Am J Cardiol. (Among 156 patients treated with simvastatin in doses of 40, 80 or 160 mg/day for 6 weeks, 1 [0.7%] taking 80 and 3 [2.1%] taking 160 developed ALT levels >3 times ULN).
Dart A, Jerums G, Nicholson G, d’Emden M, Hamilton-Craig I, Tallis G, Best J, et al. (1997). A multicenter, double-blind, one-year study comparing safety and efficacy of atorvastatin versus simvastatin in patients with hypercholesterolemia. Am J Cardiol. (Among 177 patients treated with atorvastatin or simvastatin, there were no important elevations in ALT, AST or CPK).
März W, Wollschläger H, Klein G, Neiss A, Wehling M. (1999). Safety of low-density lipoprotein cholestrol reduction with atorvastatin versus simvastatin in a coronary heart disease population (the TARGET TANGIBLE trial). Am J Cardiol. (Controlled trial of simvastatin vs atorvastatin [10 to 40 mg of either] for 14 weeks in 2856 patients; ALT elevations occurred in 2.4% of simvastatin and 2.5% of atorvastatin patients; few withdrawals and no mention of clinically apparent liver injury).
Heuer T, Gerards H, Pauw M, Gabbert HE, Reis HE. (2000). Med Klin (Munich). (4 patients with liver injury due to statins: 3 taking simvastatin and 1 pravastatin for 8-24 months presenting with jaundice [bilirubin 1.9 to 7.4 mg/dL, ALT 39 to 841 U/L, Alk P 266 to 353 U/L], resolving within 3 months of stopping in all).
Kanathur N, Mathai MG, Byrd RP, Fields CL, Roy TM. (2001). Simvastatin-diltiazem drug interaction resulting in rhabdomyolysis and hepatitis. Tenn Med. (53 year old developed fatigue and nausea 3 years after starting simvastatin and 3 months after starting diltiazem [bilirubin 2.4 mg/dL, ALT 1707 U/L, Alk P 330 U/L, CPK 1390 U/L, protime 23 seconds], values returning to normal 10 days after stopping).
Punthakee Z, Scully LJ, Guindi MM. (2001). OOi TC. Liver fibrosis attributed to lipid lowering medications: two cases. J Intern Med. (63 year old woman developed ALT elevations [443 U/L] without symptoms after 4 years of therapy with simvastatin, biopsy showed chronic hepatitis and fibrosis, laboratory tests improving 2 months after stopping).
Gagné C, Gaudet D, Bruckert E, Ezetimibe Study Group. (2002). Efficacy and safety of ezetimibe coadministered with atorvastatin or simvastatin in patients with homozygous familial hypercholesterolemia. Circulation. (Prospective trial comparing the combination of ezetimibe and either atorvastatin or simvastatin to the statin alone in 50 patients with homozygous familial hypercholesterolemia; side effects were similar, two patients on combination therapy had ALT elevations >3 times ULN, but both resolved).
Heart Protection Study Collaborative Group. (2002). MRC/BHF Heart Protection Study of cholesterol lowering with simvastatin in 20536 high-risk individuals: a randomized placebo-controlled trial. Lancet. (Large controlled trial of simvastatin vs placebo; ALT levels >2 times ULN occurred in 1.3% of patients on simvastatin vs 1.8% on placebo; ALT >4 times ULN in 0.42% vs 0.31%, not significantly different).
Parra JL, Reddy KR. (2003). Hepatotoxicity of hypolipidemic drugs. Clin Liver Dis. (Review and discussion of individual lipid lowering agents; rate of ALT elevations during simvastatin therapy similar to that with placebo; summarizes case reports and small case series of hepatic injury due to simvastatin).
Bays HE, Dujovne CA, McGovern ME, White TE, Kashyap ML, Hutcheson AG, Crouse JR, Advicor Versus Other Cholesterol-Modulating Agents Trial Evaluation. (2003). Comparison of once-daily, niacin extended-release/lovastatin with standard doses of atorvastatin and simvastatin (the Advicor Versus Other Cholesterol-Modulating Agents Trial Evaluation [ADVOCATE]). Am J Cardiol. (Controlled trial comparing lovastatin combined with niacin to atorvastatin or simvastatin alone in 315 patients for 16 weeks; no patient had confirmed ALT elevation >3 times ULN).
Matsuzawa Y, Kita T, Mabuchi H, Matsuzaki M, Nakaya N, Oikawa S, Saito Y, et al. (2003). J-LIT Study Group. Sustained reduction of serum cholesterol in low-dose 6-year simvastatin treatment with minimum side effects in 51,321 Japanese hypercholesterolemic patients. Circ J. (Large open label study of simvastatin [5 to 10 mg/day] in 52,421 Japanese patients for up to 6 years; hepatic adverse events occurred in 1% and “hepatitis” [ALT or AST >120 U/L] in 0.16%; no deaths from liver injury).
Ashar U, Desai D, Bhaduri A. (2003). Flutamide-induced hepatotoxicity with possible potentiation by simvastatin. J Assoc Physicians India. (65 year old man developed jaundice 1 month after starting flutamide while on simvastatin [bilirubin 33.5 mg/dL, ALT 646 U/L, Alk P 290 U/L]; role of simvastatin uncertain).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 3 of which were attributed to statins including simvastatin in 1 and cerivastatin in 2).
Chalasani N, Aljadhey H, Kesterson J, Murray MD, Hall SD. (2004). Patients with elevated liver enzymes are not at higher risk for statin hepatotoxicity. Gastroenterology. (Retrospective analysis of electronic records of patients with pre-existing aminotransferase elevations, found similar rates of severe ALT or AST elevations with or without statin [atorvastatin, simvastatin or fluvastatin] therapy [0.6% vs 0.4%]).
Zhao XQ, Morse JS, Dowdy AA, Heise N, DeAngelis D, Frohlich J, Chait A, et al. (2004). Safety and tolerability of simvastatin plus niacin in patients with coronary artery disease and low high-density lipoprotein cholesterol (The HDL Atherosclerosis Treatment Study). Am J Cardiol. (Controlled trial of simvastatin and niacin vs placebo in 160 patients for up to 3 years; side effects were similar in the two groups, with AST elevations >3 times ULN in 2 patients on simvastatin/niacin and one on placebo).
de Denus S, Spinler SA, Miller K, Peterson AM. (2004). Statins and liver toxicity: a meta-analysis. Pharmacotherapy. (Systematic review of 13 large controlled trials of statins with at least 48 weeks of therapy in 43,390 patients; overall odds ratio for liver test abnormalities with statins versus placebo was 1.26; lovastatin 1.78; simvastatin 1.06; pravastatin 1.00, and fluvastatin, 3.54).
Bays HE, Ose L, Fraser N, Tribble DL, Quinto K, Reyes R, Johnson-Levonas AO, et al., Ezetimibe Study Group. (2004). A multicenter, randomized, double-blind, placebo-controlled, factorial design study to evaluate the lipid-altering efficacy and safety profile of the ezetimibe/simvastatin tablet compared with ezetimibe and simvastatin monotherapy in patients with primary hypercholesterolemia. Clin Ther. (Controlled trial of various doses of ezetimibe, simvastatin or the combination vs placebo for 12 weeks in 1528 patients with hypercholesterolemia; confirmed ALT elevations >3 times ULN occurred in 0.7% on placebo, 0.7% of ezetimibe, 1.1% on simvastatin and 1.5% on the combination).
Jacobson TA. (2004). Comparative pharmacokinetic interaction profiles of pravastatin, simvastatin, and atorvastatin when coadministered with cytochrome P450 inhibitors. Am J Cardiol. (Pharmacokinetic studies of drug-drug interactions demonstrated that drugs that inhibit CYP 3A4, the major P450 drug metabolizing enzyme [itraconazole, clarithromycin, verapamil], cause increases in blood levels of simvastatin and atorvastatin, but have little effect on pravastatin levels).
Masana L, Mata P, Gagné C, Sirah W, Cho M, Johnson-Levonas AO, Meehan A, et al., Ezetimibe Study Group. (2005). Long-term safety and, tolerability profiles and lipid-modifying efficacy of ezetimibe coadministered with ongoing simvastatin treatment: a multicenter, randomized, double-blind, placebo-controlled, 48-week extension study. Clin Ther. (Trial comparing addition of ezetimibe vs placebo to ongoing simvastatin therapy for hypercholesterolemia for up to 48 weeks; only one instance of ALT levels >3 times ULN and no case of clinically apparent liver injury in 355 patients on the combination).
Alsheikh-Ali AA, Karas RH. (2005). Adverse events with concomitant amiodarone and statin therapy. Prev Cardiol. (Review of MedWatch adverse event reports for proportion that included combination with amiodarone; 1.0% for simvastatin, 0.7% atorvastatin and 0.4% pravastatin; 77% muscle, 30% liver involvement).
Cokça F, Ozkan S, Nergisoglu G, Memikoglu O, Azap A. (2005). Statin toxicity: a situation that mimics viral hepatitis. Int J Clin Pharmacol Ther. (44 year old woman developed rhabdomyolysis 2 months after being switched from fluvastatin to simvastatin with clinical features suggesting viral hepatitis, but no jaundice [ALT 1,196 U/L, AST 1,200 U/L, CPK 119,300 U/L], myoglobin in serum resulting in renal failure requiring dialysis, but ultimate full recovery).
Charles EC, Olson KL, Sandhoff BG, McClure DL, Merenich JA. (2005). Evaluation of cases of severe statin-induced transaminitis within a large health maintenance organization. Am J Med. (Among 23,000 patients on statins in a health plan, 17 had ALT elevation >10 times ULN attributable to statin use; 10 on simvastatin, 5 lovastatin, and 2 atorvastatin; onset 2 days to 4 years after starting; 10 symptomatic; all resolved within 2-8 weeks, except one death; 3 of 7 recurred on rechallenge, 5 of 6 tolerated switching to another statin).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al., Spanish Group for the Study of Drug-Induced Liver Disease. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Analysis of 461 cases of drug induced liver disease enrolled between 1984 to 2004 in a Spanish Registry; 11 cases were attributed to “statins”, but no specific agent caused more than 4 cases).
Ballantyne CM, Abate N, Yuan Z, King TR, Palmisano J. (2005). Dose-comparison study of the combination of ezetimibe and simvastatin (Vytorin) versus atorvastatin in patients with hypercholesterolemia: the Vytorin Versus Atorvastatin (VYVA) study. Am Heart J. (Controlled trial of ezetimibe/simvastatin vs atorvastatin in 1902 patients with hypercholesterolemia, ALT elevations >3 times ULN occurred in 1.1% on atorvastatin and none on ezetimibe/simvastatin).
Khorashadi S, Hasson NK, Cheung RC. (2006). Incidence of statin hepatotoxicity in patients with hepatitis C. Clin Gastroenterol Hepatol. (Electronic record review of rate of ALT elevations in patients with hepatitis C with or without statin therapy and controls on statin therapy found no differences between the three groups [20%, 24% and 17%]; severe abnormalities most frequent in patients with chronic hepatitis C not on statin [6.6% vs 1.2%]).
Law M, Rudnicka AR. (2006). Statin safety: a systematic review. Am J Cardiol. (Review of safety of statins; 38 cases of acute liver failure submitted to MedWatch by end of 1999, which gives an estimated rate of 1 per million person years of use; rate of confirmed ALT elevations >3 times ULN is 0.1% with statins and 0.04% with placebo).
Ricaurte B, Guirguis A, Taylor HC, Zabriskie D. (2006). Simvastatin-amiodarone interaction resulting in rhabdomyolysis, azotemia, and possible hepatotoxicity. Ann Pharmacother. (72 year old developed muscle pain and dark urine after 10 weeks of amiodarone and 4 weeks of simvastatin therapy [ALT 748 U/L, CK 19,620 U/L; no mention of bilirubin or Alk P], resolving within 3 months of stopping both drugs; enzyme elevations likely due to rhabdomyolysis rather than hepatitis).
Conforti A, Magro L, Moretti U, Scotto S, Motola D, Salvo F, Ros B, et al. (2006). Fluvastatin and hepatic reactions: a signal from spontaneous reporting in Italy. Drug Saf. (Italian Pharmacovigilance Group review of 35,757 adverse reaction reports; 1260 due to statins of which 178 were hepatic: 69 [36%] fluvastatin, 37 [21%] atorvastatin, 50 [28%] simvastatin, 16 [9%] pravastatin, 6 [3%] rosuvastatin; proportion reporting rate based on number of prescriptions was highest for fluvastatin [~9] compared to other agents [~2-3]; 26 fluvastatin cases described as “hepatitis”, but no details given except that most cases occurred within 90 days of starting).
Goldberg RB, Guyton JR, Mazzone T, Weinstock RS, Polis A, Edwards P, Tomassini JE, et al. (2006). Ezetimibe/simvastatin vs atorvastatin in patients with type 2 diabetes mellitus and hypercholesterolemia: the VYTAL study. Mayo Clin Proc. (Controlled trial of atorvastatin vs simvastatin/ezetimibe in 1229 patients with diabetes and hypercholesterolemia; confirmed ALT elevations >3 times ULN occurred in 0.3% of atorvastatin vs no simvastatin/ezetimibe treated patient, and no clinically apparent liver injury).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (In WHO database of fatal adverse drug reactions from 1968-2003 included 4690 reports of deaths from liver disease due to medications: none of the statins were in the top 20 suspected causes of acute liver failure due to medications).
Lata S, Chudy B. (2006). Przegl Lek. (67 year old woman developed jaundice and pruritus 10 months after starting simvastatin [bilirubin 8.2 mg/dL, ALT 165 U/L, Alk P 502 U/L], resolving within 7 weeks of stopping: Case 1).
Silva MA, Swanson AC, Gandhi PJ, Tataronis GR. (2006). Statin-related adverse events: a meta-analysis. Clin Ther. (Metaanalysis of adverse event rates in 18 placebo controlled trials of six statins in 71,108 patients; ALT elevations >3 times ULN occurred in 1.7% of statin vs 1.4% of placebo recipients; event rates highest with atorvastatin, lowest with fluvastatin).
Alla V, Abraham J, Siddiqui J, Raina D, Wu GY, Chalasani NP, Bonkovsky HL. (2006). Autoimmune hepatitis triggered by statins. J Clin Gastroenterol. (Three cases of autoimmune hepatitis arising after simvastatin or atorvastatin therapy 6, 20 and 20 weeks after starting [bilirubin 11.3, 3.4 and 5.5 mg/dL, ALT 1749, 1170 and 155 U/L, Alk P of 228, 160, and 203 U/L, all being ANA or SMA positive in titers of 1:40 to 1:160], all responding to prednisone/azathioprine and requiring long term mono-therapy with azathioprine or mycophenolate).
Dale KM, White CM, Henyan NN, Kluger J, Coleman CI. (2007). Impact of statin dosing intensity on transaminase and creatine kinase. Am J Med. (Metaanalysis of rates of ALT and CPK elevations in nine controlled studies comparing low vs high doses of statins; ALT elevations >3 times ULN occurred in 1.5% of high- and 0.4% of low-intensity statin groups, effect particularly seen with hydrophilic [pravastatin and atorvastatin] compared to lipophilic agents [simvastatin and lovastatin]).
Silva M, Matthews ML, Jarvis C, Nolan NM, Belliveau P, Malloy M, Gandhi P. (2007). Meta-analysis of drug-induced adverse events associated with intensive-dose statin therapy. Clin Ther. (Metaanalysis of rates of adverse events in 4 controlled trials in 108,049 patient years comparing standard to intensive-dose statin therapy; increased risk of ALT elevations >3 times ULN with intensive therapy [odds ratio 4.5; absolute risk 1.2%], but no mention of clinically apparent liver injury).
Alsheikh-Ali AA, Karas RH. (2007). Safety of lovastatin/extended release niacin compared with lovastatin alone, atorvastatin alone, pravastatin alone, and simvastatin alone (from the United States Food and Drug Administration adverse event reporting system). Am J Cardiol. (Analysis of MedWatch reports of adverse events found no excess in liver related adverse event reports per million prescription due to lovastatin alone [2.3] vs niacin alone [2.5] vs the combination [3.2], but slightly higher rates with atorvastatin [4.5], simvastatin [5.7] and pravastatin [4.9], but data relied upon spontaneous reporting).
Ose L, Johnson-Levonas A, Reyes R, Lin J, Shah A, Tribble D, Musliner T, Vytorin Extension Study Group. (2007). A multi-centre, randomised, double-blind 14-week extension study examining the long-term safety and efficacy profile of the ezetimibe/simvastatin combination tablet. Int J Clin Pract. (Continuation of trial [Bayes 2004] with 1104 patients continuing in extension study of simvastatin vs simvastatin/ezetimibe in various dosages; confirmed ALT elevations >3 times ULN occurred in 1.3% on simvastatin alone and 1.5% on the combination; no cases of clinically apparent liver injury).
Bhardwah SS, Chalasani N. (2007). Lipid-lowering agents that cause drug-induced hepatotoxicity. Clin Liver Dis. (Review of hepatotoxicity of statins; reported rates of ALT or AST elevations >3 times ULN: atorvastatin 0.7%, fluvastatin 1.2%, lovastatin 0.6%, pravastatin 1.4%, rosuvastatin 0% and simvastatin 1.8%. Usually asymptomatic, individual case reports of autoimmune hepatitis).
Alsheikh-Ali AA, Maddukuri PV, Han H, Karas RH. (2007). Effect of the magnitude of lipid lowering on risk of elevated liver enzymes, rhabdomyolysis, and cancer: insights from large randomized statin trials. J Am Coll Cardiol. (Systematic review of relationship between LDL cholesterol lowering effects and adverse events in 23 statin treatment arms representing 309,506 person years of therapy; positive and graded relationship between statin dose [simvastatin, lovastatin and atorvastatin] and rates of ALT elevations, but no independent relationship to degree of LDL cholesterol decrease).
Escobar C, Echarri R, Barrios V. (2008). Relative safety profiles of high dose statin regimens. Vasc Health Risk Manag. (Review of efficacy and safety of use of higher doses of statins to achieve lower LDL cholesterol levels; ALT elevations are more frequent [2-3%] with higher than lower [~1%] doses).
Tuteja S, Pyrsopoulos NT, Wolowich WR, Khanmoradi K, Levi DM, Selvaggi G, Weisbaum G, et al. (2008). Simvastatin-ezetimibe-induced hepatic failure necessitating liver transplantation. Pharmacotherapy. (70 year old woman developed acute liver failure 10 weeks after addition of ezetimibe to long term simvastatin therapy [1.5 years], with ALT 842→2595 U/L, Alk P 217 U/L, bilirubin 0.4→23.7 mg/dL, INR rising to 2.0 and emergency liver transplant: Case 2).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 cases were attributed to atorvastatin, 3 to simvastatin/ezetimibe, and one each to pravastatin, fluvastatin, and simvastatin, but most cases were mild or not clearly attributable to the statin therapy).
Bays H. (2008). Safety of niacin and simvastatin combination therapy. Am J Cardiol. (Review of safety of the combination of niacin and simvastatin; ALT elevations associated mostly with slow release [SR], rather than the extended [ER] or intermediate [IR] release formulations of niacin).
Guyton JR, Brown BG, Fazio S, Polis A, Tomassini JE, Tershakovec AM. (2008). Lipid-altering efficacy and safety of ezetimibe/simvastatin coadministered with extended-release niacin in patients with type IIa or type IIb hyperlipidemia. J Am Coll Cardiol. (Controlled trial comparing niacin alone vs simvastatin/ezetimibe vs the triple combination for 24 weeks in 1220 patients with hypercholesterolemia; confirmed ALT elevations >3 times ULN occurred in 0.4% on niacin, 0.4% on simvastatin/ezetimibe and 0.5% on all three).
Martin JE, Cavanaugh TM, Trumbull L, Bass M, Weber F, Aranda-Michel J, Hanaway M, et al. (2008). Incidence of adverse events with HMG-CoA reductase inhibitors in liver transplant patients. Clin Transplant. (Retrospective review of adverse events associated with statin and fibrate use in 69 patients with liver transplants; myalgias problematic in 5, myopathy in 1, but none had significant ALT elevations or hepatitis related to medication).
Neuvonen PJ, Backman JT, Niemi M. (2008). Pharmacokinetic comparison of the potential over-the-counter statins simvastatin, lovastatin, fluvastatin and pravastatin. Clin Pharmacokinet. (Review of literature on pharmacokinetics of statins; simvastatin and lovastatin are metabolized extensively by the P450 system and levels are affected by inhibitors or inducers of CYP 3A4 [itraconazole, erythromycin, verapamil, diltiazem, cyclosporine], whereas fluvastatin and pravastatin are minimally if at all affected).
MRC/BHF Heart Protection Study Collaborative Group. (2009). Armitage J, Bowman L, Collins R, Parish S, Tobert J. Effects of simvastatin 40 mg daily on muscle and liver adverse effects in a 5-year randomized placebo-controlled trial in 20,536 high-risk people. BMC Clin Pharmacol. (Analysis of muscle and hepatic adverse events in controlled trial of simvastatin [40 mg] vs placebo daily for 5 years in 20,536 UK patients; hepatitis occurred in 1 patient on simvastatin [ALT 257 U/L] at 7 months, 9 months later presenting with acute hepatitis and jaundice] and 1 on placebo [later attributed to septicemia]; ALT elevations >3 times ULN occurred in 0.75% on simvastatin and 0.63% on placebo).
Robinson JG, Ballantyne CM, Grundy SM, Hsueh WA, Parving HH, Rosen JB, Adewale AJ, et al. (2009). Lipid-altering efficacy and safety of ezetimibe/simvastatin versus atorvastatin in patients with hypercholesterolemia and the metabolic syndrome (from the VYMET study). Am J Cardiol. (Controlled trial of ezetimibe/simvastatin versus atorvastatin alone in 1128 patients with metabolic syndrome and hypercholesterolemia; adverse event rates were similar in the two groups, but consecutive ALT or AST elevations >3 times ULN occurred in 0.3% of atorvastatin vs 1.4% of ezetimibe/simvastatin treated patients).
Abraldes JG, Albillos A, Bañares R, Turnes J, González R, García-Pagán JC, Bosch J. (2009). Simvastatin lowers portal pressure in patients with cirrhosis and portal hypertension: a randomized controlled trial. Gastroenterology. (Controlled trial of simvastatin [20-40 mg/d] vs placebo for 30 days assessing effects on hepatic venous pressure gradient [HVPG] in 59 patients with portal hypertension found slight decrease in HVPG and improvement in indocyanine green clearance; no changes in ALT levels or evidence of liver injury).
Russo MW, Scobey M, Bonkovsky HL. (2009). Drug-induced liver injury associated with statins. Semin Liver Dis. (Review of statin hepatotoxicity and the several forms of liver injury that they can cause, including silent aminotransferase elevations, cholestatic and hepatocellular hepatitis and autoimmune hepatitis-like syndromes, all of which are rare).
Björnsson E, Jacobsen EI, Kalaitzakis E. (2012). Hepatotoxicity associated with statins: reports of idiosyncratic liver injury post-marketing. J Hepatol. (Between 1988 and 2010, the Swedish registry received 217 adverse event reports possibly related to statins, 124 [57%] being liver related, 73 of which could be evaluated; 2 were fatal and one led to liver transplant; 3 had positive rechallenge; 43 [59%] were hepatocellular, 22 [30%] cholestatic and 8 [11%] mixed; 30 were due to atorvastatin, 28 simvastatin, 11 fluvastatin, 2 pravastatin and 2 rosuvastatin, arising after 30 to 248 days; simvastatin injury was hepatocellular in 75% of instances [one case was fatal, one led to transplant] and was estimated to occur in 0.9 per 100,000 person years of exposure).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen over a 12 year period at a large hospital in Bangalore, India, 5 [2%] were attributed to atorvastatin, but no other statin listed].
Idilman R, Bektas M, Cinar K, Toruner M, Cerit ET, Doganay B, Erden E, et al. (2010). The characteristics and clinical outcome of drug-induced liver injury: a single-center experience. J Clin Gastroenterol. (Among 170 patients with drug induced liver injury seen at a single referral center in Turkey between 2001 and 2007, 14 were attributed to statins which were hepatocellular in 10 and cholestatic in 4; no details provided).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 6 were attributed to statins: 2 atorvastatin, 2 simvastatin [one with ezetimibe] and 2 cerivastatin).
Vaverkova H, Farnier M, Averna M, Missault L, Viigimaa M, Dong Q, Shah A, et al. (2012). Lipid-altering efficacy of ezetimibe/simvastatin 10/20 mg compared to rosuvastatin 10 mg in high-risk patients with and without type 2 diabetes mellitus inadequately controlled despite prior statin monotherapy. Cardiovasc Ther. (In a randomized trial in patients with hypercholesterolemia, ALT or AST elevations >3 times ULN occurred in none 303 patients receiving rosuvastatin versus 0.7% of 312 on the combination of simvastatin and ezetimibe).
Xu CF, Xue Z, Bing N, King KS, McCann LA, de Souza PL, Goodman VL, et al. (2012). Concomitant use of pazopanib and simvastatin increases the risk of transaminase elevations in patients with cancer. Ann Oncol. (Retrospective analysis of ALT elevations in 895 patients with cancer enrolled in 22 studies of pazopanib; among those who were also receiving a statin, rates of ALT elevations above 3 times ULN were higher [17% to 21%] than in those not on a statin [14%]).
Bergmann OM, Kristjansson G, Jonasson JG, Björnsson ES. (2012). Jaundice due to suspected statin hepatotoxicity: a case series. Dig Dis Sci. (3 women and 1 man, ages 55 to 85 years, developed jaundice 3, 3, 11 and 30 months after starting atorvastatin [n=3] or simvastatin [n=1], with hepatocellular or mixed injury [peak bilirubin 4.0-7.4 mg/dL, ALT 446-2987 U/L, Alk P 174-716 U/L, ANA positive in 1], all resolving spontaneously in 1-3 months).
Björnsson E, Jacobsen EI, Kalaitzakis E. (2012). Hepatotoxicity associated with statins: reports of idiosyncratic liver injury post-marketing. J Hepatol. (Between 1988 and 2010, the Swedish registry received 217 adverse event reports possibly related to statins, 124 [57%] being liver related, 73 of which could be evaluated: 2 were fatal and one led to liver transplant; 3 had positive rechallenge; 43 [59%] were hepatocellular, 22 [30%] cholestatic and 8 [11%] mixed; 30 were due to atorvastatin, 28 simvastatin, 11 fluvastatin, 2 pravastatin and 2 rosuvastatin, arising after 30-248 days; atorvastatin injury was more likely to be cholestatic and was estimated to occur in 2.9 per 100,000 person years).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including one case [without jaundice] attributed to simvastatin).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to statins or lipid lowering agents).
Russo MW, Hoofnagle JH, Gu J, Fontana RJ, Barnhart H, Kleiner DE, Chalasani N, et al. (2014). Spectrum of statin hepatotoxicity: Experience of the drug-induced liver injury network. Hepatology. (Among 1,188 cases of drug induced liver disease collected in the US between 2004 to 2012, 22 [2%] were attributed to statins, including atorvastatin [8], simvastatin [5], rosuvastatin [4], fluvastatin [2], pravastatin [2] and lovastatin [1]; median age was 60 years and 68% were women; 9 cases were cholestatic and 12 hepatocellular [6 with autoimmune features]; the latency ranged widely, from 1 month to 10 years; only one case was fatal [a man with preexisting cirrhosis presenting with acute-on-chronic liver failure]).
Bays H, Cohen DE, Chalasani N, Harrison SA. (2014). An assessment by the Statin Liver Safety Task Force: 2014 update. J Clin Lipidol. (Review of the safety of statins including their use in patients with liver disease recommending that liver tests be obtained before therapy, but that routine monitoring is not necessary and that statins can be safety used in patients with nonalcoholic liver disease, and are probably safe in other forms of chronic liver disease and after liver transplantation).
Ooba N, Sato T, Wakana A, Orii T, Kitamura M, Kokan A, Kurata H, et al. (2014). A prospective stratified case-cohort study on statins and multiple adverse events in Japan. PLoS One. (Among 6877 patients started on statins between 2008 and 2010, 139 developed an increase in ALT or AST deemed likely due to the drug with no significant differences among those treated with pra-, ator-, flu-, pita- or rosu-vastatin).
Macedo AF, Taylor FC, Casas JP, Adler A, Prieto-Merino D, Ebrahim S. (2014). Unintended effects of statins from observational studies in the general population: systematic review and meta-analysis. BMC Med. (Systematic review of 90 studies of 48 different "unintended effects" of statins with evidence of an increased risk of myopathy [Odds Ratio: OR=2.6] and raised liver enzymes [OR=1.5]).
(2014). Drugs for lipids. Treat Guidel Med Lett. (Concise recommendations on management of hyperlipidemia mentions that 1-2% of patients on high doses of statins develop ALT elevations [above 3 times ULN], but that there is not always cross sensitivity to this side effect and that patients with mild-to-moderate ALT elevations can tolerate statins; no discussion of clinically apparent liver).
Bastida C, Also MA, Pericas JM, Letang E, Tuset M, Miró JM. (2014). Enferm Infecc Microbiol Clin. (52 year old woman with HIV infection on darunavir/ritonavir, lamivudine and raltegravir was switched from atorvastatin [40 mg] to simvastatin [80 mg] daily and developed rhabdomyolysis 3 weeks later [bilirubin 0.5 mg/dL, ALT 787 U/L, CK 34,960 U/L], possibly due to drug-drug interactions between simvastatin and ritonavir).
Perdices EV, Medina-Cáliz I, Hernando S, Ortega A, Martín-Ocaña F, Navarro JM, Peláez G, et al. (2014). Hepatotoxicity associated with statin use: analysis of the cases included in the Spanish Hepatotoxicity Registry. Rev Esp Enferm Dig. (Among 858 cases of drug induced liver injury enrolled in a Spanish Registry between 1994 and 2012, 47 [5.5%] were attributed to statins [16 atorvastatin, 13 simvastatin, 12 fluvastatin, 4 lovastatin and 2 pravastatin] usually with a hepatocellular pattern of injury, 8.5% with autoimmune features, chronic injury in 19%, and no liver related deaths).
Chen GL, Hsiao FY, Dong YH, Shen LJ, Wu FL. (2014). Statins and the risk of liver injury: a population-based case-control study. Pharmacoepidemiol Drug Saf. (Among 2165 Taiwanese patients hospitalized for liver injury between 2002 and 2009, use of statins was not more frequent than among 16,600 hospitalized controls, except for use of high doses of rosuvastatin [adjusted odds ratio of 2.29]).
Peña-Irún Á. (2015). Med Clin (Barc). (66 year old woman was found to have asymptomatic elevations of ALT [92 U/L] and AST [55 U/L] with ANA positivity [1:320] 5 months after starting simvastatin, the abnormalities resolving 1 month after stopping).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases [3.4%] were attributed to statins, including 8 to atorvastatin, 8 simvastatin, 7 rosuvastatin, 4 pravastatin, 2 fluvastatin and 2 lovastatin).
Chang CH, Chang YC, Lee YC, Liu YC, Chuang LM, Lin JW. (2015). Severe hepatic injury associated with different statins in patients with chronic liver disease: a nationwide population-based cohort study. J Gastroenterol Hepatol. (Among 37,929 Taiwanese persons with chronic liver disease started on statin therapy for hyperlipidemia between 2005 and 2009, there were 912 incident cases of hospitalization for liver injury, rates being similar for the 6 different statins used [1.94-2.95 per 100,000 person-days], but higher in those on high doses of atorvastatin [40 or 80 mg daily]).
Dybro AM, Damkier P, Rasmussen TB, Hellfritzsch M. (2016). Statin-associated rhabdomyolysis triggered by drug-drug interaction with itraconazole. BMJ Case Rep. (47 year old woman taking simvastatin [80 mg daily] for two years developed rhabdomyolysis 3 weeks after starting a ten day course of itraconazole [CK 30,855 U/L, myoglobin 5,046 μmol/L], resolving completely over the next month).
Kim HS, Lee SH, Kim H, Lee SH, Cho JH, Lee H, Yim HW, et al. (2016). Statin-related aminotransferase elevation according to baseline aminotransferases level in real practice in Korea. J Clin Pharm Ther. (Among 21,233 Korean patients starting statin therapy between 2009 and 2013, abnormal ALT or AST values above 3 times ULN were more frequent among those with mild baseline elevations).
Clarke AT, Johnson PC, Hall GC, Ford I, Mills PR. (2016). High dose atorvastatin associated with increased risk of significant hepatotoxicity in comparison to simvastatin in UK GPRD cohort. PLoS One. (Analysis of the Clinical Practice Research Database of UK patients initiating statin treatment between 1997 and 2006 identified 71 of 76,411 developing liver dysfunction while on atorvastatin [0.09%] vs 101 of 164,407 on simvastatin [0.06%], rates being higher with higher [40 or 80 mg] vs lower [10 or 20 mg] doses of atorvastatin [0.44% vs 0.07%], but not with higher vs lower doses of simvastatin [0.09% vs 0.05%]).
Wang LY, Huang YS, Perng CL, Huang B, Lin HC. (2016). Statin-induced liver injury in an area endemic for hepatitis B virus infection: risk factors and outcome analysis. Br J Clin Pharmacol. (Analysis of the Taipei Veterans Hospital database from 2008 to 2012 identified 108 patients with statin-associated liver injury [including 28 rosu-, 20 flu-, 17 sim-, 11 pra-, 8 lo-, and 8 pita-vastatin] most of which 75 [69%] were mild and only one fatal [80 year old on rosu-], and there were no differences in disease features or peak enzyme or bilirubin levels between HBsAg positive vs negative [n=16 vs 92]).
Goldie FC, Brogan A, Boyle JG. (2016). Ciprofloxacin and statin interaction: a cautionary tale of rhabdomyolysis. BMJ Case Rep. (62 year old woman on simvastatin for 13 years developed rhabdomyolysis 4 days after starting ciprofloxacin [bilirubin not given, ALT 240 U/L, AST 870 U/L, CPK 24,514], which resolved upon stopping; no mention of myoglobin levels).
Björnsson ES. (2017). Hepatotoxicity of statins and other lipid-lowering agents. Liver Int. (Review of the hepatotoxicity of statins mentions that atorvastatin has been the most frequently implicated statin [accounting for 30-40% of cases] in drug induced liver injury estimated to arise in 1 in 17,000 users, cholestatic in 56% and with autoimmune features in 10% and rarely fatal).
Birmingham BK, Bujac SR, Elsby R, Azumaya CT, Wei C, Chen Y, Mosqueda-Garcia R, et al. (2015). Impact of ABCG2 and SLCO1B1 polymorphisms on pharmacokinetics of rosuvastatin, atorvastatin and simvastatin acid in Caucasian and Asian subjects: a class effect?. Eur J Clin Pharmacol. (Among 96 subjects treated in an open-label, 3-way crossover study of a single oral dose of rosuvastatin [20 mg], atorvastatin [40 mg], or simvastatin [40%], Chinese and Japanese subjects had higher plasma levels than European subjects, and the differences could not be attributed entirely to hepatic transporter polymorphisms {SLCO1B1*1a and ABCG2c.421] known to be associated with higher statin levels).
Giugliano RP, Wiviott SD, Blazing MA, De Ferrari GM, Park JG, Murphy SA, White JA, et al. (2017). Long-term safety and efficacy of achieving very low levels of low-density lipoprotein cholesterol: a prespecified analysis of the IMPROVE-IT Trial. JAMA Cardiol. (Among 15,281 patients recovering from an acute cardiac syndrome treated with simvastatin [40 mg daily] with or without ezetimibe for up to 6 years, 6.4% achieved very low LDL-cholesterol levels [<30 mg/dL] and subsequently had low rates of cardiovascular events but also no increase in rates of adverse events from statins such including ALT elevations above 3 times ULN [2.2% vs 1.8-2.1%]).
Bergland Ellingsen S, Nordmo E, Lappegård KT. (2017). Recurrence and severe worsening of hepatotoxicity after reintroduction of atorvastatin in combination with ezetimibe. Clin Med Insights Case Rep. (After an acute myocardial infarction, a 70 year old woman was treated with simvastatin in doses of 40 and 80 mg and then with atorvastatin [40 mg] but developed elevated ALT levels [69 to 123 U/L] and was switched to pravastatin, but then was switched to atorvastatin with ezetimibe and developed fatigue and weakness 2 months later [bilirubin 4.3 mg/dL, ALT 2003 U/L, Alk P 164 U/L], which resolved rapidly once atorvastatin was again discontinued).
Hong SJ, Jeong HS, Ahn JC, Cha DH, Won KH, Kim W, Cho SK, et al. (2018). A phase III, multicenter, randomized, double-blind, active comparator clinical trial to compare the efficacy and safety of combination therapy with ezetimibe and rosuvastatin versus rosuvastatin monotherapy in patients with hypercholesterolemia: I-ROSETTE (Ildong Rosuvastatin & Ezetimibe for Hypercholesterolemia) randomized controlled trial. Clin Ther. (Among 396 Korean patients with hypercholesterolemia treated with rosuvastatin [5, 10 or 20 mg daily] with or without ezetimibe [10 mg daily] for 8 weeks, the percent decrease in LDL-cholesterol was higher at each dose of rosuvastatin combined with ezetimibe [overall -57% vs -44%] and the proportion of patients achieving a targeted goal of LDL-cholesterol was also higher [92% vs 80%], while there were similar rates of total adverse events [11.2% vs 11.3%], serious adverse events [0.5% vs 0.5%] as well as ALT elevations above 3 times the ULN [0.6% vs 0]).
Liang X, He Q, Zhao Q. (2018). Effect of stains on LDL reduction and liver safety: a systematic review and meta-analysis. Biomed Res Int. (In a systematic review of 16 controlled trials of statins in 74,078 patients, rates of liver test abnormalities were higher with statin therapy [odds ratio, OR=1.18] but this was significant only for fluvastatin [OR=3.5] and with higher doses [40-80 mg daily] [OD=3.6] and was not significant for statins used at low or moderate doses).
Wu X, Gong C, Weinstock J, Cheng J, Hu S, Venners SA, Hsu YH, et al. (2018). Associations of the SLCO1B1 polymorphisms with hepatic function, baseline lipid levels, and lipid-lowering response to simvastatin in patients with hyperlipidemia. Clin Appl Thromb Hemost. (Among 542 Chinese subjects with hyperlipidemia treated with simvastatin [20 mg daily] for 8 weeks, polymorphisms in the SCLO1B1 gene were associated with slight differences in ALT and AST levels but no data were provided on the effect of simvastatin on ALT or lipid levels or whether they changed on therapy: “Patients whose laboratory parameters were affected by the treatment were excluded during the study”).
Teschke R. (2018). Top-ranking drugs out of 3312 drug-induced liver injury cases evaluated by the Roussel Uclaf Causality Assessment Method. Expert Opin Drug Metab Toxicol. (A compilation of national and international databases on drug induced liver injury identified the ten top-ranking causes which included two statins, atorvastatin [ranking 3^rd^] and simvastatin [ranking 6^th^]).
Yebyo HG, Aschmann HE, Kaufmann M, Puhan MA. (2019). Comparative effectiveness and safety of statins as a class and of specific statins for primary prevention of cardiovascular disease: A systematic review, meta-analysis, and network meta-analysis of randomized trials with 94,283 participants. Am Heart J. (Metaanalyses of 40 trials of statins that enrolled 94,283 patients followed for a median of 1 year for efficacy and safety reported that statins as a class increased the risk of hepatic dysfunction by 6% with fluvastatin having the highest relative risk).
Godinho R, Bugnon S, Gracin T, Tataw J. (2019). Severe rhabdomyolysis-induced acute kidney injury following concomitant use of Genvoya® (EVG/COBI/FTC/TAF) and simvastatin; a case report. BMC Nephrol. (54 year old man with HIV infection, chronic hepatitis C, acute hepatitis A and hypercholesterolemia on simvastatin developed myalgias, weakness and worsening jaundice 10 days after switching antiretroviral regimen to a fixed combination of elvitegravir, emtricitabine, tenofovir and cobicistat a potent inhibitor of CYP 3A4 [ALT 2081 U/L, AST 7017 U/L, GGT 198 U/L, bilirubin 7.6 mg/dL, CPK 185,190 U/L and creatinine 6.1 mg/dL], improving ultimately after stopping the antiretroviral combination regimen).
(2019). Lipid-lowering drugs. Med Lett Drugs Ther. (Concise review of the mechanism of action, relative efficacy, safety and costs of lipid lowering drugs including statins, ezetimibe, PCSK9 inhibitors, bile acid sequestrants, fibric acid derivatives niacin and fish oil, mentions that statin therapy is associated with ALT elevations above 3 times ULN in 1-3% of patients but “whether statins actually cause liver damage is unclear”).
Hung TH, Tsai CC, Lee HF. (2019). Statin use in cirrhotic patients with infectious diseases: A population-based study. PLoS One. (Analysis of the Taiwan National Health Insurance Database identified 816 patients with cirrhosis receiving statins [including simvastatin] who were hospitalized for bacterial infections and similar number of cirrhotic controls not on statins, found a lower 30-day mortality with statins: 5.3% vs 9.8%).
Simon TG. (2020). When less is more: dosing simvastatin in decompensated cirrhosis. Lancet Gastroenterol Hepatol. (Editorial in response to Pose et al [2020] discusses the possible beneficial effects of statins in patients with cirrhosis and the issue of increased rate of muscle toxicity with 40 vs to 20 mg daily).
Pose E, Napoleone L, Amin A, Campion D, Jimenez C, Piano S, Roux O, et al. (2020). Safety of two different doses of simvastatin plus rifaximin in decompensated cirrhosis (LIVERHOPE-SAFETY): a randomised, double-blind, placebo-controlled, phase 2 trial. Lancet Gastroenterol Hepatol. (Among 50 patients with decompensated cirrhosis treated with simvastatin [20 or 40 mg daily] and rifaximin vs placebo for 12 weeks, 3 of 16 patients on 40 mg of simvastatin developed muscle pains and marked elevations in CPK, ALT and AST, whereas the 14 patients on 20 mg did not develop signs of either muscle or liver toxicity).
Wong K, Podboy A, Lavezo J, Goel A. (2020). Dead meat: glecaprevir/pibrentasvir-induced statin myonecrosis. Dig Dis Sci. (60 year old man with compensated cirrhosis from HCV with coronary artery disease on simvastatin for many years developed myalgias, muscle weakness and jaundice 6 weeks after starting glecaprevir and pibrentasvir [bilirubin 6.1 mg/dL, ALT 512 U/L, AST 1646 U/L, CPK >16,800 U/L, INR 2.1, creatinine 2.0, myoglobin in urine], with improvement on stopping simvastatin but no follow up information given).
Hopewell JC, Offer A, Haynes R, Bowman L, Li J, Chen F, Bulbulia R, et al. (2020). Independent risk factors for simvastatin-related myopathy and relevance to different types of muscle symptom. Eur Heart J. (In a combined analysis of 3 large clinical trials in patients with cardiovascular disease treated with simvastatin for a mean of 3.4 years, 171 of 58,390 participants [0.1%] developed myopathy [muscle pain and CK levels above 10 times ULN], and risk was higher with higher doses, in Asian subjects, women, and persons with higher BMI and multiple comorbidities as well as with SLCO1B1 genotype).
Muñoz AE, Pollarsky F, Marino M, Cartier M, Míguez C, Vázquez H, Álvarez D, et al. (2021). Safety of chronic simvastatin treatment in patients with decompensated cirrhosis: many adverse events but no liver injury. Dig Dis Sci. (Among 30 patients with cirrhosis [Child’s Class A in 6, B in 22, and C in 2] treated with simvastatin [40 mg daily] for up to one year, adverse events were frequent [53%], including myalgia in 23% and myonecrosis in 13% but all resolved with dose modification or interruption and no patient developed evidence of liver injury).
Balasubramanian R, Maideen NMP. (2021). HMG-CoA reductase inhibitors (statins) and their drug interactions involving CYP enzymes, P-glycoprotein and OATP transporters-an overview. Curr Drug Metab. (Systematic review of literature on drug-drug interactions with statins and their clinical significance mentions that toxicity can be enhanced by inhibitors of CYP3A4 [ator-, sim- and lo-vastatin] as well as by inhibitors of P glycoprotein and OATP1B1 [most statins including rosuvastatin] with specific recommendations for the most common inhibitors).
Sung S, Al-Karaghouli M, Kalainy S, Cabrera Garcia L, Abraldes JG. (2021). A systematic review on pharmacokinetics, cardiovascular outcomes and safety profiles of statins in cirrhosis. BMC Gastroenterol. (Systematic review of literature suggests that rosuvastatin and pitavastatin pharmacokinetics are unchanged in patients with Child’s Class A cirrhosis as opposed to atorvastatin and pravastatin, although unlike rosuvastatin, simvastatin, atorvastatin and pravastatin have been assessed in clinical trials in cirrhotic patients).
Onfiani G, Nascimbeni F, Carubbi F. (2021). A case of statin-induced liver injury with positive rechallenge with a second statin. Is there a class effect?. J Basic Clin Physiol Pharmacol. (58 year old woman on long term simvastatin therapy developed ALT elevations 2 months after dose increase from 10 mg to 20 mg daily [ALT 314 U/L] without symptoms, Alk P or bilirubin elevations which was normal 2 months after stopping, but was elevated again without symptoms or jaundice 2 months after starting rosuvastatin in a dose of 5 mg daily [ALT 542 U/L], slowing falling to normal 5 months after stopping statins a second time).
Cai T, Abel L, Langford O, Monaghan G, Aronson JK, Stevens RJ, Lay-Flurrie S, et al. (2021). Associations between statins and adverse events in primary prevention of cardiovascular disease: systematic review with pairwise, network, and dose-response meta-analyses. BMJ. (Systematic review of placebo controlled trials of statins for cardiovascular disease prevention identified 62 publications with 120,456 patients and found an increased risk of muscle symptoms, liver test abnormalities, renal insufficiency and eye conditions for all 7 statins, but not muscle disorders or diabetes; rosuvastatin having relatively high risk for muscle symptoms and renal abnormalities and also was also associated with eye conditions and diabetes while atorvastatin and lovastatin had highest risk for liver abnormalities).

## OTHER REFERENCE LINKS

1 Recent References on Simvastatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=simvastatin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Simvastatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=simvastatin)